# Amikacin

## OVERVIEW

### Introduction

Amikacin is a parenterally administered, broad spectrum aminoglycoside antibiotic typically used for severe gram negative infections. Despite widespread use, amikacin has not been associated with instances of acute liver injury.

### Background

Amikacin (am" i kay' sin) is a semisynthetic aminoglycoside with a particularly broad antimicrobial activity which is used for severe bacterial infections caused by sensitive agents including those resistant to gentamicin or tobramycin. Like other aminoglycosides, amikacin is thought to act by binding to bacterial ribosomes and inhibiting protein synthesis. Nevertheless, amikacin is considered bacteriocidal as well as bacteriostatic. Amikacin and other aminoglycosides are typically used in combination with a penicillin or cephalosporin for treatment of severe infections with Pseudomonas aeruginosa, Enterobacter, Klebsiella, Serratia and other gram-negative bacteria resistant to less toxic antibiotics. Amikacin is most commonly used for septicemia, bacterial endocarditis, peritonitis, meningitis, pelvic inflammatory disease and pneumonia. Amikacin is also used in therapy of tuberculosis in combination with other antitubercular drugs. Amikacin was approved for use in the United States in 1981 and is available in several generic parenteral formulations. The typical adult dose is 15 mg/kg per day im or iv, usually in two or three divided doses over 5 to 10 days. The dose of amikacin must be modified based upon renal function and monitoring of drug levels is advisable. Common side effects include dizziness, headache, confusion, nausea and skin rash. Importantly, dose related adverse effects of amikacin include oto- and nephrotoxicity, which are shared by all aminoglycosides.

### Hepatotoxicity

Intravenous and intramuscular therapy with amikacin has not been linked to serum alkaline phosphatase or aminotransferase elevations, and no convincing cases of symptomatic or icteric hepatotoxicity due to amikacin have been published. Other aminoglycosides have been linked to very rare cases of cholestatic hepatitis, that typically arise within 1 to 3 weeks of starting therapy, often associated with skin rash, fever and sometimes eosinophilia. Recovery typically occurs within 1 to 2 months and chronic injury has not been described. Amikacin as well as other aminoglycosides are not mentioned in large case series of drug induced liver disease and acute liver failure; thus, hepatic injury due to amikacin is very rare if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the rare occurrence of cholestatic jaundice after aminoglycoside therapy is unknown, but suspected to be a part of a generalized hypersensitivity reaction. Uptake of aminoglycosides into hepatocytes is limited and they are rapidly excreted in the urine; high concentrations are found in mainly in renal tubular cells and hair cells of inner ear perhaps explaining why they are more likely to cause nephro- or oto- rather than hepatotoxicity.

### Outcome and Management

The outcome of hepatic injury due to aminoglycosides is usually benign. Acute liver failure and chronic bile duct vanishing syndrome have been not been described after their use. Patients with any form of aminoglycoside hepatotoxicity should probably avoid future systemic aminoglycoside use.

References to the safety and potential hepatotoxicity of amikacin are provided in the Overview section on the Aminoglycosides.

Drug Class: Aminoglycosides

Other Drugs in the Class: Gentamicin, Neomycin, Plazomicin, Streptomycin, Tobramycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Amikacin – Generic

DRUG CLASS

Aminoglycosides

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Amikacin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Amikacin | 37517-28-5 | C22-H43-N5-O13 | Amikacin chemical structure

## OTHER REFERENCE LINKS

1. Recent References on Amikacin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Amikacin/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Amikacin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=amikacin)